# Baloxavir

## OVERVIEW

### Introduction

Baloxavir is an inhibitor of the influenza cap-dependent endonuclease enzyme and is used as therapy of influenza A and B. Baloxavir is given as a single, one-time dose and has not been associated with serum enzyme elevations or with clinically apparent liver injury.

### Background

Baloxavir (ba lox' a vir) marboxil (mar box' il) is an oral, influenza cap-dependent endonuclease inhibitor that blocks the initiation of mRNA synthesis in influenza viruses, which results in a decrease in influenza virus particle production. Baloxavir is active against both influenza A and B viruses but has no activity against other common upper respiratory tract viruses. In addition, resistance to baloxavir can develop rapidly even after a single dose. Baloxavir was approved as therapy of uncomplicated influenza A and B in persons 12 years or older in the United States in 2018. Baloxavir is available as tablets of 40 and 80 mg under the brand name of Xofluza. It is recommended as a single oral dose of 40 mg for patients who weigh 40 to 80 kg and 80 mg for patients weighing above 80 kg, administered as soon as possible and within 48 hours after onset of symptoms. Side effects are uncommon but may include mild diarrhea, nausea, headache and upper respiratory tract symptoms that are also common with influenza itself. Rare but potentially serious adverse events include hypersensitivity reactions and secondary bacterial infections.

### Hepatotoxicity

In clinical trials, there was little evidence that baloxavir caused liver injury, either in the form of serum enzyme elevations or clinically apparent liver disease. A proportion of patients with acute influenza A may have minor serum enzyme elevations during the acute illness, but these are independent of therapy and do not appear to be exacerbated by baloxavir.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

How baloxavir might cause liver injury is not known. Baloxavir marboxil is a prodrug that is converted to the active agent baloxavir in the intestines. Baloxavir is metabolized by the liver by UGT1A3 with a minor contribution of CYP 3A4 but demonstrates no significant drug-drug interactions. Baloxavir is administered as a single 40 or 80 mg dose, and the brief exposure and minimal hepatic metabolism may account for the absence of hepatotoxicity.

Drug Classes: Antiviral Agents

Other Drugs in the Class for Influenza: Amantadine, Oseltamivir, Peramivir, Rimantadine, Zanamivir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Baloxavir – Xofluza®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Baloxavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Baloxavir Marboxil | 1985606-14-1 | C27-H23-F2-N3-O7-S

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; baloxavir is not mentioned).
Núñez M. Influenza virus treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 513. (Review of hepatotoxicity of antiviral agents; baloxavir is not discussed).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that in the preregistration clinical trials, routine laboratory tests were taken on days 1, 5-6, 15 and 22, and elevated ALT levels occurred in <1% of 910 baloxavir recipients and in a similar proportion of 409 placebo recipients).
Yingying C. (2011). Abnormal liver chemistry in patients with influenza A H1N1. Liver Int. (Among 131 patients admitted to a hospital for influenza A H1N1, 13% had ALT and 5% Alk P elevations, but the range of values was not provided).
Koshimichi H, Ishibashi T, Kawaguchi N, Sato C, Kawasaki A, Wajima T. (2018). Safety, tolerability, and pharmacokinetics of the novel anti-influenza agent baloxavir marboxil in healthy adults: phase I study findings. Clin Drug Investig. (Among 75 healthy adults enrolled in phase I studies of baloxavir, adverse events included ALT elevations in 3 subjects, but “there were no obvious trends in laboratory values”).
Hayden FG, Sugaya N, Hirotsu N, Lee N, de Jong MD, Hurt AC, Ishida T, et al., Baloxavir Marboxil Investigators Group. (2018). Baloxavir marboxil for uncomplicated influenza in adults and adolescents. N Engl J Med. (Among 1064 patients with influenza symptoms treated with a single oral dose of baloxavir, 5 days of oseltamivir or placebo, time to symptom alleviation was shorter with baloxavir and oseltamivir than with placebo [54 and 54 vs 80 hours], while adverse event rates were similar and low; no mention of ALT elevations or hepatotoxicity).
Heo YA. (2018). Baloxavir: First global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of baloxavir for influenza virus infection; mentions that adverse events are no more frequent with baloxavir as with placebo; no mention of ALT elevations or hepatotoxicity).
Granwehr BP. (2018). In acute uncomplicated influenza, single-dose baloxavir decreased time to symptom relief compared with placebo. Ann Intern Med. (Commentary on Hayden [2018] points out that the single oral dose regimen, while no more effective than a 5 day course of oseltamivir, provides a more convenient approach to rapidly treat suspected early influenza in an outpatient setting).
(2018). Baloxavir marboxil (Xofluza) for treatment of influenza. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of baloxavir shortly after its approval in the US; mentions that it was well tolerated in clinical trials; no mention of ALT elevations or hepatotoxicity).
(2019). Antiviral drugs for treatment and prophylaxis of seasonal influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there are no data suggesting the superiority of one drug over another, they are all approved for treatment of uncomplicated influenza, should be started as soon as possible, and have been shown to shorten the duration of symptoms by one day in adults; no mention of ALT elevations or hepatotoxicity of any of the neuraminidase inhibitors or baloxavir).
Mushtaq A. (2018). Baloxavir: game-changer or much ado about nothing?. Lancet Respir Med. (Review of the evidence for efficacy of baloxavir in influenza; mentions that persons at highest risk for complications of influenza were excluded from the initial trials of its efficacy: children, pregnant women, and those with serious comorbidities).
Abraham GM, Morton JB, Saravolatz LD. (2020). Baloxavir: a novel antiviral agent in the treatment of influenza. Clin Infect Dis. (Review of the mechanism of action, microbiology, indications, clinical efficacy and toxicity of baloxavir mentions that adverse event rates are similar to those of oseltamivir and not much greater than placebo; no discussion of ALT elevations or hepatotoxicity).
Baker J, Block SL, Matharu B, Burleigh Macutkiewicz L, Wildum S, Dimonaco S, et al. (2020). Baloxavir marboxil single-dose treatment in influenza-infected children: a randomized, double-blind, active controlled phase 3 safety and efficacy trial (miniSTONE-2). Pediatr Infect Dis J. (Among 173 children less than 12 years old with influenza who were treated with a single dose of intravenous baloxavir or a 5 day course of oral oseltamivir, rates of clinical improvement were similar with the two regimens as were rates of adverse events [57% vs 46%] and there were no serious adverse events or deaths; no mention of ALT elevations or hepatotoxicity).
(2020). Antiviral drugs for influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there is no evidence that one drug is more effective than any other in treating uncomplicated influenza infections but that oseltamivir is preferred for treatment of pregnant women, hospitalized patients and those with severe, complicated or progressive illness; mentions that side effects appear to be less common with baloxavir than oseltamivir; no mention of ALT elevations or hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Baloxavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Baloxavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Baloxavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Baloxavir)